# Amivantamab

## OVERVIEW

### Introduction

Amivantamab is a bispecific monoclonal antibody that inhibits the receptors of both epidermal growth factor (EGF) and mesenchymal epithelial transition factor (MET) and is used alone or in combination with other antineoplastic agents to treat adults with locally advanced or metastatic non-small cell lung cancer that harbor EGF receptor mutations. Amivantamab when combined with other cancer agents is associated with transient elevations in serum aminotransferase levels during therapy, but it has not been convincingly linked to episodes of clinically apparent liver injury with jaundice.

### Background

Amivantamab (am” i van’ ta mab) is a fully human, bispecific monoclonal antibody that targets the receptors of both epidermal growth factor (EGF) and mesenchymal epithelial transition factor (MET). Amivantamab is typically used in combination with lazertinib or other antineoplastic agents to treat adults with locally advanced or metastatic non-small cell lung cancer (NSCLC) that harbors EGF receptor mutations. EGF receptors are frequently mutated in lung cancer resulting in excessive activation of the EGF receptor pathway which promotes cell growth and proliferation, and which may also secondarily activate the c-MET pathway. These mutations are often responsible for the drug resistance to conventional EGF receptor inhibitors, such as erlotinib and gefitinib. Amivantamab has activity against wild type EGF receptors as well as potent activity against receptors that harbor the mutant exon 20 insertion, which is found in 9% of patients diagnosed with NSCLC. When used alone, amivantamab was found to increase progression-free survival compared to placebo in patients with advanced NSCLC who harbored receptor exon 20 insertion mutations and were refractory to previous platinum-based chemotherapy. Subsequently, indications were broadened for amivantamab combined with other agents including lazertinib and carboplatin with pemetrexed even as first line therapy of advanced or metastatic NSCLC with EGF receptor mutations. Amivantamab was approved for use in the United States in 2021 and is available in solution as 350 mg in 7 mL (50 mg/mL) in single dose vials under the brand name Rybrevant. The recommended dose varies by body weight, timing, and which antineoplastic agents are given in combination, but is generally in the range of 1,000 to 2,100 mg given intravenously once weekly for 4 weeks followed by every 3 weeks until unacceptable intolerance or disease progression arises. Side effects are common with amivantamab combination therapy. Common, mild-to-moderate side effects include rash, nail toxicity, infusion reactions, fatigue, stomatitis, nausea, diarrhea, constipation, decreased appetite, edema, musculoskeletal and abdominal pain, paresthesia, and pruritus. Less frequent but potentially severe adverse events include severe infusion-related reactions, interstitial lung disease, venous thromboembolic events, severe skin rash, ocular toxicity and embryo-fetal toxicity. Many of these adverse events are probably due to the kinase inhibitors or cytotoxic agents that are coadministered with amivantamab. Its combination with lazertinib has a boxed warning about thromboembolic events, and routine anticoagulation is recommended for the first 4 months of treatment.

### Hepatotoxicity

In the prelicensure, single armed trials of amivantamab in patients with refractory, advanced or metastatic NSCLC, liver test abnormalities were frequent, with elevations in ALT in 34% of 362 participants treated. The elevations were generally mild and self-limited in course. Elevations above 5 times the upper limit of normal (ULN) occurred in only 1.4% and were not accompanied by elevations in serum bilirubin. No patient developed evidence of drug induced liver injury or clinically apparent liver injury. Increases in serum ALT levels led to infrequent dose interruptions but not to drug discontinuations. There was no placebo control used in these studies and the background rate of transient ALT elevations in this patient population, who are often receiving other antineoplastic agents, was not known. In subsequent trials of amivantamab combined with conventional chemotherapeutic agents or with lazertinib, serum ALT or AST elevations were more frequent. In patients on the combination of amivantamab with lazertinib, ALT and AST elevations arose in 65% of subjects and were above 5 times ULN in 7%. However, even those higher enzyme elevations were not accompanied by jaundice or symptoms of acute liver injury and no case was considered to have drug induced liver injury. Since approval and more widespread use of amivantamab, there have been no published case reports of clinically apparent liver injury attributed to its use. Thus, amivantamab therapy may be accompanied by transient serum aminotransferase elevations but has not been convincingly implicated in instances of clinically significant liver injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The serum enzyme elevations that arise during amivantamab therapy are probably due to other antineoplastic agents being used or the result of progression of NSCLC or other medical conditions. Amivantamab is a human monoclonal antibody and is metabolized to small oligonucleotides and nucleic acids. It is not metabolized by hepatic microsomal drug-metabolizing enzymes. On the other hand, the pathways inhibited by amivantamab (EGF and MET signaling) play a complex role in hepatic function, repair, and regeneration, and an “off target” effect of their actions might lead indirectly to hepatic injury. Because amivantamab is given in combination with other potent antineoplastic agents, it is difficult to know whether abnormalities are attributable to the monoclonal antibody or the coadministered potentially cytotoxic chemotherapeutic agents.

### Outcome and Management

The product label for amivantamab does not specifically recommend monitoring of liver tests before or during treatment. Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) or any elevations accompanied by jaundice or symptoms should lead to at least temporary cessation of both or at least one of the administered agents. There is no evidence to suggest a cross reactivity in risk for adverse events, hypersensitivity, or hepatic injury between amivantamab and kinase inhibitors or cytotoxic neoplastic agents.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies

Other EGF Receptor Targeted Kinase Inhibitors Used to Treat NSCLC: Axitinib, Erlotinib, Gefitinib, Lazertinib, Mobocertinib, Osimertinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Amivantamab – Rybrevant®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Amivantamab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Amivantamab | 2171511-58-1 (https://pubchem.ncbi.nlm.nih.gov/compound/Amivantamab) | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 25 March 2025

Abbreviations: EGF, epidermal growth factor; ULN, upper limit of the normal range.

Zimmerman HJ. Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of amivantamab).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. Multi-Discipline Review. 2021. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/761210Orig1s000MultidisciplineR.pdf (FDA review of the data on efficacy and safety of amivantamab in support of its approval for therapy of refractory, advanced or metastatic NSCLC with EGF receptor mutations in the US, mentions that liver test abnormalities were frequent in the 362 patients treated, ALT elevations arising in 34% of patients, which were above 5 times the ULN in 1.4%, leading to dose interruptions in several patients, but there were no discontinuations for serum enzyme elevations, and no instances of clinically apparent liver injury).
Neijssen J, Cardoso RMF, Chevalier KM, Wiegman L, Valerius T, Anderson GM, Moores SL, et al. Discovery of amivantamab (JNJ-61186372), a bispecific antibody targeting EGFR and MET. J Biol Chem. 2021;296:100641. (Description of the design and activity of amivantamab which binds to both the EGF receptor and MET blocking the activation of both and demonstrating in vitro better antitumor activity that inhibition of either alone). 33839159
Syed YY. Amivantamab: first approval. Drugs. 2021;81:1349-1353. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy, and safety of amivantamab shortly after its approval for use in the US, mentions common adverse events of rash, infusion reactions, paronychia, musculoskeletal pain, nausea, constipation, edema, fatigue, cough, stomatitis, and pruritus, but does not mention ALT elevations or hepatotoxicity). 34292533
Amivantamab (Rybrevant) for non-small cell lung cancer. Med Lett Drugs Ther. 2022;64:e184-e185. (Concise summary of the mechanism of action, clinical efficacy, safety, and costs of amivantamab shortly after its approval for use in NSCLC in the US mentions common side effects as well as infusion reactions despite premedication, interstitial lung disease, rash (worsened by sun exposure), and ocular toxicity, but does not mention ALT elevations or hepatotoxicity). 36384764
Chon K, Larkins E, Chatterjee S, Mishra-Kalyani PS, Aungst S, Wearne E, Subramaniam S, et al. FDA approval summary: amivantamab for the treatment of patients with non-small cell lung cancer with EGFR exon 20 insertion mutations. Clin Cancer Res. 2023;29:3262-3266. (Summary of the data on safety and efficacy of amivantamab that supported its accelerated approval by the FDA mentions that the safety review found serious adverse reactions in 30% of patients, discontinuations in 11%, fatal reactions in 2%, none of which were attributed to hepatic adverse events or ALT elevations which arose in 34% of a closely followed subset of patients, but were above 5 times the ULN in only 1.6%). 37022784
Zhou C, Tang KJ, Cho BC, Liu B, Paz-Ares L, Cheng S, Kitazono S, et al.; PAPILLON Investigators. Amivantamab plus chemotherapy in NSCLC with EGFR exon 20 insertions. N Engl J Med. 2023;389:2039-2051. (Among 308 patients with previously untreated, advanced NSCLC with EGF receptor exon 20 insertions treated with standard chemotherapy with or without amivantamab, progression-free survival was longer with addition of amivantamab [11.4 vs 6.7 months], while severe adverse events were slightly higher [37% vs 31%], but serum ALT elevation rates were similar [27% vs 32%] including those above 5 times ULN [3% vs 1%], but hypoalbuminemia was more frequent with the monoclonal therapy [41% vs 10%]; there were no discontinuations because of ALT elevations or episodes of drug induced liver injury). 37870976
Cho BC, Lu S, Felip E, Spira AI, Girard N, Lee JS, Lee SH, et al.; MARIPOSA Investigators. Amivantamab plus lazertinib in previously untreated EGFR-mutated advanced NSCLC. N Engl J Med. 2024;391(16):1486-1498. (Among 1074 adults with advanced NSCLC harboring EGF receptor mutations [exon 19 deletion or L858R] treated with lazertinib with or without amivantamab vs osimertinib, progression-free survival was longer with the combination vs osimertinib [23.7 vs 16.6 months] while serious adverse events rates were higher [49% vs 33%], as were dose reductions [59% vs 5%], discontinuations [35% vs 14%], and ALT elevations [36% vs 13%], which were above 5 times ULN in 5% vs 2%, but there were no discontinuations for liver injury). 38924756
Passaro A, Wang J, Wang Y, Lee SH, Melosky B, Shih JY, Wang J, et al.; MARIPOSA-2 Investigators. Amivantamab plus chemotherapy with and without lazertinib in EGFR-mutant advanced NSCLC after disease progression on osimertinib: primary results from the phase III MARIPOSA-2 study. Ann Oncol. 2024;35:77-90. (Among 657 patients with EGF receptor mutant, advanced NSCLC refractory of osimertinib who were treated with amivantamab and standard chemotherapy with or without lazertinib or placebo, progression-free survival was highest with amivantamab combined with lazertinib [8.3 months], vs amivantamab and chemotherapy [6.3 months] and chemotherapy alone [4.2 months], but so were serious adverse events [57% vs 32% vs 20%], but rates of ALT elevations were similar [21% vs 20% vs 28%] including elevations above 5 times ULN [5% vs 5% vs 4%] and there were no reports of liver injury with jaundice). 37879444
Leighl NB, Akamatsu H, Lim SM, Cheng Y, Minchom AR, Marmarelis ME, Sanborn RE, et al.; PALOMA-3 Investigators. Subcutaneous versus intravenous amivantamab, both in combination with lazertinib, in refractory epidermal growth factor receptor-mutated non-small cell lung cancer: primary results from the phase III PALOMA-3 study. J Clin Oncol. 2024;42:3593-3605. (Among 418 patients with refractory, EGF receptor mutated NSCLC treated with lazertinib and either subcutaneous or intravenous amivantamab, the objective response rate was similar while infusion related reactions were fewer with sc dosing [13% vs 66%] and therapy was in general better tolerated, ALT elevations arising in 20% vs 21% and were above 5 times ULN in 1% of both groups). 38857463
Lazertinib (Lazcluze) for non-small cell lung cancer. Med Lett Drugs Ther. 2024;66:e176-e177. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of lazertinib shortly after its approval as therapy in combination with amivantamab in 2024, mentions the many side effects of combination therapy but does not mention ALT elevations or hepatotoxicity). 39466312
Fu X, Zeng D, Li M, Wu J, Yang Y, Mao Q, Qiu W, et al. Post-marketing safety surveillance of amivantamab: a real world study based on the FDA adverse event reporting system. Expert Opin Drug Saf. 2025:1-9. Epub ahead of print. (Analysis of the FDA Adverse Event Reporting System [FAERS] from 2019 to 2024 found 893 reports of amivantamab among which 16 were attributed to “hepatobiliary disorders” but no details given). 40001304

## OTHER REFERENCE LINKS

1. Recent References on Amivantamab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Amivantamab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Amivantamab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Amivantamab)